# Contact Us

LiverTox® is a living document and is continuously expanded, revised and updated. As a part of this process, the LiverTox staff welcomes all questions and comments from its users. Particularly helpful would be specific comments on the accuracy of statements, citations, writing and content, which will be of enormous help in ensuring the reliability of the information. Please report any web site problems such as broken links, as well.

Please direct your comments or questions by email to: the LiverTox Administrative Assistant at livertox@mail.nih.gov.

The LiverTox staff will attempt to answer all queries in a timely fashion. Thank you.